# Atovaquone

## OVERVIEW

### Introduction

Atovaquone is a naphthoquinone used for the prevention and treatment of Pneumocystis jevorici (formerly carinii) pneumonia and, in combination with proguanil, prevention and treatment of P. falciparum malaria. Atovaquone therapy is associated with low rates of serum enzyme elevations and has been linked to only rare cases of clinically apparent liver injury.

### Background

Atovaquone (a toe' va kwone) is a synthetic naphthoquinone that acts by interfering with mitochondrial electron transport in susceptible organisms. Atovaquone is effective against chloroquine resistant P. falciparum, but is associated with a high rate of resistance, for which reason it is usually given in combination with other agents, most typically with proguanil. Atovaquone was approved for use in the United States in 1992 and the combination with proguanil in 2000. Current indications include treatment and prevention of Pneumocystis jiroveci (formerly carinii) pneumonia (atovaquone alone) and treatment and prevention of falciparum malaria (combined with proguanil). It is sometimes used off-label as a second line agent for Toxoplasma gondii. Atovaquone is available in tablets of 250 and 500 mg and as a suspension of 750 mg/5 mL under the brand name Mepron. A fixed combination of 250 mg of atovaquone and 100 mg of proguanil is available generically and under the brand name Malarone, which is used in a 3 day regimen (4 tablets daily) to treat drug resistant P. falciparum malaria and for the period of exposure (1 tablet daily) to prevent chloroquine resistant Plasmodium falciparium and vivax malaria. A pediatric formulation is also available. The recommended dosage of atovaquone varies by different indications. Specific recommendations on the use of atovaquone for management of opportunistic infections among persons with HIV infection are available at: http://aidsinfo.nih.gov/guidelines/, and recommendations on treatment and prevention of malaria on the CDC website at: http://www.cdc.gov/malaria/. Common side effects of atovaquone include headache, fever, anxiety, insomnia, vivid dreams, nausea, diarrhea, skin rash and itching.

### Hepatotoxicity

Atovaquone has been linked to serum aminotransferase elevations in a small proportion of patients (1% to 6%). There have also been rare reports of clinically apparent, acute liver injury due to atovaquone. In one published case report (Case 1), the onset of injury was 25 days after starting (and a few days after stopping) treatment. The pattern of serum enzyme elevations was cholestatic. Immunoallergic manifestations (fever, rash and eosinophilia) were not prominent and autoantibodies were not present. The liver injury resolved within 2 months of stopping the medication. Because a combination of proguanil and atovaquone was used, either agent could have been responsible for the injury. Atovaquone has also been linked to rare instances of Stevens Johnson syndrome, which is frequently accompanied by mild liver injury or liver enzyme elevations.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which atovaquone might cause liver injury is unknown. Atovaquone is minimally metabolized by the liver, while proguanil is metabolized by the cytochrome P450 system (CYP 2C19). Either a toxic or an immunogenic metabolite may be responsible for the injury.

### Outcome and Management

The severity of hepatic injury due to atovaquone varies from mild serum enzyme elevations that are asymptomatic and transient, to clinically apparent liver injury with jaundice. Acute liver failure, chronic hepatitis and vanishing bile duct syndrome have not been reported after atovaquone therapy. There does not seem to be cross reactivity to hepatic injury among the various antimalarial agents and switching to other drug can be safely done.

Drug Class: Antimalarial Agents, see also Proguanil

## CASE REPORT

### Case 1. Cholestatic hepatitis after course of atovaquone/proguanil for malaria prophylaxis.

[Modified from: Grieshaber M, Lämmli J, Marcus L. Acute hepatitis and atovaquone/proguanil. J Travel Med 2005; 12: 289-90. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/16256055)]

A 31 year old man developed jaundice and abdominal pain a few days after a 25 day course of atovaquone (250 mg) and proguanil (100 mg) for malaria prophylaxis during travel. Other symptoms included poor appetite, itching, fatigue and dark urine. He had no previous history of liver disease or exposures to hepatitis and did not abuse alcohol. On examination, he had mild fever (37.5 ^o^C) and was jaundiced. There was no mention of rash or eosinophilia. Serum bilirubin was mildly elevated at 2.9 mg/dL, and both ALT and alkaline phosphatase levels were prominently increased (Table). Tests for viral hepatitis A, B, C and E were negative as were autoantibody markers. MRI of the abdomen showed a normal appearing liver and biliary system. A liver biopsy was not done. His symptoms gradually improved and serum enzyme abnormalities eventually resolved approximately 8 weeks after initial presentation.

#### Key Points

Medication: | Atovaquone and proguanil
Pattern: | Cholestatic (R=1.7)
Severity: | 2+ (jaundice, hospitalization)
Latency: | 25 days
Recovery: | 8 weeks
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Alk P* (U/L) | Bilirubin* (mg/dL) | Other
4 weeks | 1 weeks | 320 | 445 | 2.9 | LDH 610 U/L
| 2 weeks | 330 | 410 | 2.2
| 3 weeks | 710 | 330 | 0.6
7 weeks | 4 weeks | 310 | 240 | 0.5
| 5 weeks | 280 | 190 | 0.5
| 6 weeks | 75 | 115 | 0.5
| 7 weeks | 60 | 110 | 0.5
11 weeks | 8 weeks | 25 | 105 | 0.5
Normal Values | | <40 | <92 | <1.2

* Estimated from Figure 1.

#### Comment

A mild case of cholestatic hepatitis typical of drug induced liver injury, and the only medications being used were atovaquone and proguanil, either of which may have been the cause. The somewhat delayed decline in serum enzymes is typical of cholestatic forms of drug induced liver injury.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Atovaquone – Mepron®

DRUG CLASS

Antimalarial Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Atovaquone)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Atovaquone | 95233-18-4 | C22-H19-Cl-O3 | Chemical Structure for Atovaquone

## ANNOTATED BIBLIOGRAPHY

References updated: 02 February 2017

Zimmerman HJ. Antiprotozoal agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 623-5. (Expert review of hepatotoxicity published in 1999; atovaquone is not discussed).
Vinetz JM, Clain J, Bounkeua V, Eastman RT, Fidock D. Chemotherapy of malaria. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1383-418. (Textbook of pharmacology and therapeutics).
Høgh B, Clarke PD, Camus D, Nothdurft HD, Overbosch D, Günther M, Joubert I, et al.; Malarone International Study Team. Atovaquone-proguanil versus chloroquine-proguanil for malaria prophylaxis in non-immune travelers: a randomised, double-blind study. Malarone International Study Team. Lancet 2000; 356: 1888-94. (Controlled trial of atovaquone vs chloroquine combined with proguanil as malaria prophylaxis in 1008 travelers; efficacy was similar, but gastrointestinal upset was more common with chloroquine [20% vs 12%]; among 180 with laboratory testing “No clinically important laboratory abnormalities were identified”). 11130385
Overbosch D, Schilthuis H, Bienzle U, Behrens RH, Kain KC, Clarke PD, Toovey S, et al. Malarone International Study Team. Atovaquone-proguanil versus mefloquine for malaria prophylaxis in nonimmune travelers: results from a randomized, double-blind study. Clin Infect Dis 2001; 33: 1015-21. (Controlled trial of atovaquone-proguanil vs mefloquine of malaria prophylaxis in 483 travelers; similar efficacy [100%], but neuropsychiatric side effects were more common with mefloquine [29% vs 14%] including insomnia, anxiety, vivid dreams, dizziness and trouble concentrating; no mention of liver injury and ALT levels were not monitored). 11528574
Camus D, Djossou F, Schilthuis HJ, Høgh B, Dutoit E, Malvy D, Roskell NS, et al.; International Malarone Study Team. Atovaquone-proguanil versus chloroquine-proguanil for malaria prophylaxis in nonimmune pediatric travelers: results of an international, randomized, open-label study. Clin Infect Dis 2004; 38: 1716-23. (Controlled trial of atovaquone vs chloroquine combined with proguanil as malaria prophylaxis in 221 children; efficacy was similar [100%], but side effects were slightly more frequent with chloroquine [mostly gastrointestinal]; no mention of liver injury or ALT elevations). 15227617
Taylor WR, White NJ. Antimalarial drug toxicity: a review. Drug Saf 2004; 27: 25-61. (Review of the toxicities and side effects of antimalarial agents; mentions that atovaquone/proguanil can cause minor ALT elevations, but clinically apparent hepatotoxicity is not mentioned). 14720085
Grieshaber M, Lämmli J, Marcus L. Acute hepatitis and atovaquone/proguanil. J Travel Med 2005; 12: 289-90. (31 year old man developed jaundice and abdominal pain 25 days after starting atovaquone/proguanil prophylaxis [bilirubin 2.9 mg/dL, ALT 320 U/L, Alk P 445 U/L], resolving slowly over next 8 weeks: Case 1). 16256055
Patel SN, Kain KC. Atovaquone/proguanil for the prophylaxis and treatment of malaria. Expert Rev Anti Infect Ther 2005; 3: 849-61. (Review of chemistry, clinical results and safety of atovaquone/proguanil; states that the combination is well tolerated, and ALT elevations are not mentioned). 16307498
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol 2010; 105: 2396-404. (313 cases of drug induced liver injury were seen over a 12 year period at a large hospital in Bangalore, India; none were attributed to antimalarials). 20648003
Askling HH, Bruneel F, Burchard G, Castelli F, Chiodini PL, Grobusch MP, Lopez-Vélez R, Paul M, et al; European Society for Clinical Microbiology and Infectious Diseases Study Group on Clinical Parasitology. Management of imported malaria in Europe. Malar J 2012;11: 328. (Recommendations on treatment of malaria from a European panel; atovaquone-proguanil is a first line treatment for uncomplicated P. falciparum malaria; side effects of ALT elevations and hepatotoxicity are not mentioned). 22985344
Kimura M, Koga M, Kikuchi T, Miura T, Maruyama H. Efficacy and safety of atovaquone-proguanil in treating imported malaria in Japan: the second report from the research group. Parasitol Int 2012; 61: 466-9. (30 cases of P. falciparum or vivax malaria in Japan were treated successfully with atovaquone-proguanil; one patient with P. falciparum had abnormal liver tests [bilirubin 2.0 mg/dL, ALT 294 U/L] with thrombocytopenia [48,000/μL] that resolved within 4 weeks of stopping treatment). 22484597
Cordel H, Cailhol J, Matheron S, Bloch M, Godineau N, Consigny PH, Gros H, et al. Atovaquone-proguanil in the treatment of imported uncomplicated Plasmodium falciparum malaria: a prospective observational study of 553 cases. Malar J 2013; 12: 399. (Among 553 French travelers treated for uncomplicated malaria with atovaquone-proguanil, parasitemia cleared in all patients by day 7 and only 3 patients relapsed; side effects included nausea or vomiting [17%], headache [7%], and rash [2%]. "As observed in the literature, this study did not reveal any liver toxicity"). 24200190
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to an antimalarial agent). 24552865
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study from Iceland, 96 cases of drug induced liver injury were identified over a 2 year period [2010 and 2011], but none were attributed to an antimalarial agent). 23419359
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to an antimalarial agent). 25754159
Advice for travelers. Treat Guidel Med Lett 2015: 57 (1466): 52-8. (Concise guidelines on prevention of malaria in travelers indicates that atovaquone-proguanil taken once daily is an effective prophylaxis against choloroquine resistant Plasmodium species, "...generally the best tolerated prophylactic, but it can cause headache, insomnia, GI disturbances and mouth ulcers, and is expensive. Single case reports of Stevens Johnson syndrome and hepatitis have been published"). 25853663

## OTHER REFERENCE LINKS

1. Recent References on Atovaquone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=atovaquone+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Atovaquone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=atovaquone)